# Ezetimibe

## OVERVIEW

### Introduction

Ezetimibe is an inhibitor of intestinal cholesterol absorption that is widely used in the therapy of hypercholesterolemia, usually in combination with other agents. Ezetimibe therapy is associated with a low rate of serum aminotransferase elevations and clinically apparent liver injury due to ezetimibe occurs, but is rare.

### Background

Ezetimibe (e zet' i mibe) is a synthetic azetidinone that inhibits cholesterol absorption from the intestine. Ezetimibe acts by binding to and inhibiting the Niemann-Pick C1-like 1 protein (NPC1), the major transporter of cholesterol in the intestinal brush border. Ezetimibe by itself lowers serum cholesterol, but the inhibition of cholesterol absorption is usually followed by a compensatory increase in hepatic cholesterol synthesis, a response that can be blocked by hydroxymethylglutaryl coenzyme A (HMG-CoA) reductase inhibitors [statins]. For this reason, ezetimibe is commonly used in combination with a statin. Addition of ezetimibe to a maximized dose of statins generally lowers LDL-cholesterol levels by 22% to 24%. Ezetimibe was approved for use in the United States in 2002 and is usually recommended as an adjunctive therapy to diet or in combination with a statin in management of patients with hypercholesterolemia at high risk for cardiovascular or cerebrovascular disease. It is also used alone in patients who are intolerant of statins and can be combined with other lipid-lowering agents (such as fibrates or anti-PCSK9 monoclonal antibodies). Ezetimibe is available in 10 mg tablets generically and under the brand name Zetia, and the usually recommended dose is 10 mg daily. Ezetimibe is also available in a fixed combination with simvastatin (20 or 40 mg) under the trade name Vytorin and with atorvastatin (10, 20, 40 or 80 mg) under the trade name Liptruzet. Ezetimibe has achieved wide scale acceptance and several million prescriptions are filled yearly. Common side effects of ezetimibe include diarrhea and flatulence. Rare, potentially severe adverse effects include hypersensitivity reactions, myopathy and rhabdomyolysis.

### Hepatotoxicity

Therapy with ezetimibe alone or in combination with other lipid lowering agents is associated with a low rate of serum enzyme elevations (0.5% to 1.5%), but most elevations are self-limited and not associated with jaundice or symptoms. In large randomized controlled trials, ezetimibe by itself has not been associated with a higher rate of serum ALT elevation than occurs with placebo therapy. However, the addition of ezetimibe to statin therapy has been associated with a slight increase in the likelihood of serum aminotransferase elevations or rates of discontinuation due to liver test abnormalities. Clinically apparent acute liver injury due to ezetimibe has been reported, but is rare. Furthermore, because this agent is often used in combination with other cholesterol lowering drugs, the role of ezetimibe in these reports is not always well defined. The latency to onset of clinically apparent liver injury attributed to ezetimibe has ranged from 2 to 10 months and the pattern of serum enzyme elevations has ranged from hepatocellular to cholestatic. Cases of autoimmune hepatitis-like injury have been described in patients taking the combination of ezetimibe and a statin, and the role of ezetimibe in these reactions is difficult to assign (Case 1). A single instance of vanishing bile duct syndrome due to ezetimibe has been described in a patient who continued on ezetimibe for several months despite presence of jaundice.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

Ezetimibe is metabolized by the P450 system, but has little effect on the pharmacokinetics of other drugs, perhaps because it is rapidly conjugated and excreted in the bile as a glucuronide. Cases of an autoimmune hepatitis-like syndrome suggest immune mediated injury may be the cause of some clinically apparent liver injury due to ezetimibe.

### Outcome and Management

The mild ALT elevations associated with ezetimibe therapy are usually self-limited and do not require dose modification. Cases of acute liver injury due to ezetimibe have usually been self-limited, but instances of vanishing bile duct syndrome, chronic autoimmune hepatitis and acute liver failure (Case 2) have been reported. Patients with autoimmune hepatitis-like liver injury due to ezetimibe may warrant corticosteroid therapy, but the dose and duration of therapy should be kept to a minimum. The product label for ezetimibe includes a warning about enzyme elevations during combination therapy and recommends screening for liver test abnormalities before starting treatment and monitoring tests during therapy if clinically indicated or elevations are suspected. Ezetimibe has a unique mechanism of action and chemical structure, and there is no reason to suspect cross sensitivity to liver injury between ezetimibe and other cholesterol lowering agents. Ezetimibe is often used in patients with intolerance to statins because of muscle pains and myopathy.

Drug Class: Antilipemic Agents

Other Drugs in the Subclass, Statins: Atorvastatin, Fluvastatin, Lovastatin, Pitavastatin, Pravastatin, Rosuvastatin, Simvastatin

## CASE REPORTS

### Case 1. Autoimmune hepatitis like injury arising during atorvastatin and ezetimibe therapy.(1)

A 50 year old woman developed nausea, abdominal pain and jaundice with features of autoimmune hepatitis during combination therapy with atorvastatin (80 mg daily for 16 months) and ezetimibe (10 mg daily for 3 months). There was no previous history of liver disease and laboratory tests had been normal shortly before ezetimibe was started. She had multiple other medical problems including coronary artery disease, osteoarthritis, hypothyroidism, and gastroesophageal reflux. She drank little alcohol and had no exposures to hepatitis. On presentation, she had epigastric tenderness but no rash or fever. Laboratory tests showed raised bilirubin and serum enzymes (Table). Both ezetimibe and atorvastatin were stopped. Tests for hepatitis A, B and C were negative and ultrasound imaging showed no evidence of biliary obstruction. She tested positive for antinuclear antibody and antibodies to double-stranded DNA (anti-dsDNA). A liver biopsy showed hepatitis with eosinophils and plasma cells. Over the ensuing few weeks, her symptoms resolved and laboratory tests improved. Six weeks after onset, her liver tests were normal and autoantibody levels had fallen. She was started on rosuvastatin for her hypercholesterolemia and did well without recurrence of symptoms or liver test abnormalities.

#### Key Points

Medication: | Ezetimibe (10 mg daily) and atorvastatin (80 mg daily)
Pattern: | Hepatocellular (R=10.7)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 12 weeks for ezetimibe; 16 months for atorvastatin
Recovery: | ~6 weeks
Other medications: | Furosemide, diltiazem, diclofenac, acetaminophen, atenolol, ibuprofen, clopidogrel, thyroxine, lactulose, and nitrates

#### Laboratory Values

Time After Starting | Time After Stopping | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 17 | 75 | 0.5 | Atorvastatin 80 mg (13 months)
0 | | Ezetimibe (10 mg/day) started
12 weeks | 0 | 1626 | 468 | 4.6 | ANA 1:160, anti-dsDNA 38
13 weeks | 10 days | 858 | 424 | 5.1 | ANA 1:80, anti-dsDNA 31
14 weeks | 15 days | 266 | 340 | 2.7
18 weeks | 45 days | 20 | 100 | 0.6 | ANA 1:40, anti-dsDNA 6
Normal Values | | <42 | <130 | <1.2

#### Comment

A well documented example of drug induced autoimmune hepatitis, with resolution when atorvastatin and ezetimibe were stopped. Particularly convincing was the decrease in autoantibody titers with drug withdrawal. Ezetimibe is perhaps the most likely candidate to have caused the liver injury, but cases of autoimmune hepatitis-like injury from atorvastatin have been reported with latency to onset of more than a year.

### Case 2. Acute liver failure attributed to simvastatin and ezetimibe therapy.(2)

A 70 year old woman developed abnormal liver tests ten weeks after switching from simvastatin (40 mg) monotherapy to the combination of simvastatin (40 mg) and ezetimibe (10 mg) daily. She had a history of coronary artery disease, hypertension, depression and hypercholesterolemia and had been on simvastatin for one and a half years with normal serum enzymes (Table). Despite stopping both simvastatin and ezetimibe when elevations in serum enzymes were first found, the patient developed jaundice and progressive symptoms of liver failure. Tests for hepatitis A, B and C were negative as were autoimmune markers. A liver biopsy showed changes suggestive of drug induced liver injury and severe cholestasis. She subsequently developed progressive encephalopathy and worsening coagulation indices, and was listed and underwent successful liver transplantation approximately 4 weeks after stopping therapy. In follow up for two years after transplantation, liver enzymes were normal.

#### Key Points

Medication: | Ezetimibe and simvastatin
Pattern: | Hepatocellular (R=25)
Severity: | 5+ (emergency liver transplantation)
Latency: | 10 weeks to liver test abnormalities, 12 weeks to jaundice
Recovery: | None
Other medications: | Enalapril, escitalopram chronically

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 19 | 65 | 0.5 | Before starting simvastatin
0 | | 14 | 51 | 0.4 | On simvastatin before ezetimibe
10 weeks | 0 | 842 | | 0.4 | Simvastatin & ezetimibe stopped
12 weeks | 2 weeks | 2595 | 217 | 15.8 | Admitted
14 weeks | 4 weeks | 1951 | 116 | 21.6 | INR=2.0
Emergency liver transplantation performed
Post-op day 1 | | 209 | 83 | 8.4
Post-op day 23 | | 39 | 82 | 1.0
2 years after transplant | | 18 | 79 | 0.5
Normal Values | | <56 | <126 | <1.2

#### Comment

The onset of injury 10 weeks after starting ezetimibe suggests that it was the cause of the acute liver injury, but onset of hepatitis due to simvastatin can occur months to years after its initiation. Since ezetimibe is usually used in combination with a statin, it is usually difficult to attribute the liver injury to ezetimibe alone. This is one of the few case reports of acute liver failure due to a cholesterol lowering agent.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ezetimibe – Generic, Zetia®

DRUG CLASS

Antilipemic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=ezetimibe)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ezetimibe | 163222-33-1 | C24- H21-F2-N-O3

## CITED REFERENCES

1 van Heyningen C. (2005). Drug-induced acute autoimmune hepatitis during combination therapy with atorvastatin and ezetimibe. Ann Clin Biochem.
2 Tuteja S, Pyrsopoulos NT, Wolowich WR, Khanmoradi K, Levi DM, Selvaggi G, Weisbaum G, et al. (2008). Simvastatin-ezetimibe-induced hepatic failure necessitating liver transplantation. Pharmacotherapy.

## ANNOTATED BIBLIOGRAPHY

References updated: 01 December 2021

Abbreviations used: ANA, antinuclear antibody; HDL, high density lipoprotein; LDL, low density lipoprotein; OD, odds ratio.

De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic medications. Lipid lowering agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 519-40. (Review of hepatotoxicity of lipid lowering agents mentions that cases of severe cholestatic, as well as autoimmune, hepatitis have been linked to ezetimibe use).
Gurgle H, Blumenthal DK. Drug therapy for dyslipidemias. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 605-618. (Textbook of pharmacology and therapeutics).
Gagné C, Gaudet D, Bruckert E, Ezetimibe Study Group. (2002). Efficacy and safety of ezetimibe coadministered with atorvastatin or simvastatin in patients with homozygous familial hypercholesterolemia. Circulation. (Prospective trial comparing the combination of ezetimibe and either atorvastatin or simvastatin to the statin alone in 50 patients with homozygous familial hypercholesterolemia; side effects were similar, one patients on combination therapy and one on statins alone had ALT elevations above 3 times ULN, but both resolved).
Bays HE, Ose L, Fraser N, Tribble DL, Quinto K, Reyes R, Johnson-Levonas AO, et al., Ezetimibe Study Group. (2004). A multicenter, randomized, double-blind, placebo-controlled, factorial design study to evaluate the lipid-altering efficacy and safety profile of the ezetimibe/simvastatin tablet compared with ezetimibe and simvastatin monotherapy in patients with primary hypercholesterolemia. Clin Ther. (Controlled trial of various doses of ezetimibe, simvastatin or the combination vs placebo for 12 weeks in 1528 patients with hypercholesterolemia; confirmed ALT elevations above 3 times ULN occurred in 0.7% on placebo, 0.7% on ezetimibe alone, 1.1% on simvastatin alone and 1.5% on the combination).
Masana L, Mata P, Gagné C, Sirah W, Cho M, Johnson-Levonas AO, Meehan A, et al., Ezetimibe Study Group. (2005). Long-term safety and, tolerability profiles and lipid-modifying efficacy of ezetimibe coadministered with ongoing simvastatin treatment: a multicenter, randomized, double-blind, placebo-controlled, 48-week extension study. Clin Ther. (Trial comparing addition of ezetimibe vs placebo to ongoing simvastatin therapy for hypercholesterolemia for up to 48 weeks; only one instance of ALT levels above 3 times ULN and no case of clinically apparent liver injury in 355 patients on the combination).
Kosoglou T, Statkevich P, Johnson-Levonas AO, Paolini JF, Bergman AJ, Alton KB. (2005). Ezetimibe: a review of its metabolism, pharmacokinetics and drug interactions. Clin Pharmacokinet. (Review of biochemistry, pharmacology, mechanism of action, drug interactions of ezetimibe; ezetimibe is extensively conjugated to glucuronide in the intestine and liver and while it has inhibitory activity against CYP 3A4, it does not exhibit major drug-drug interactions with other agents that are metabolized by this pathway).
van Heyningen C. (2005). Drug-induced acute autoimmune hepatitis during combination therapy with atorvastatin and ezetimibe. Ann Clin Biochem. (50 year old woman developed jaundice 16 months after starting atorvastatin and 3 months after starting ezetimibe therapy [bilirubin 4.6 mg/dL, AST 1626 U/L, Alk P 468 U/L, positive ANA and anti-dsDNA], resolving 6 weeks after stopping both: Case 1).
Ballantyne CM, Abate N, Yuan Z, King TR, Palmisano J. (2005). Dose-comparison study of the combination of ezetimibe and simvastatin (Vytorin) versus atorvastatin in patients with hypercholesterolemia: the Vytorin Versus Atorvastatin (VYVA) study. Am Heart J. (Controlled trial of ezetimibe/simvastatin vs atorvastatin in 1902 patients with hypercholesterolemia, ALT elevations above 3 times ULN occurred in 1.1% on atorvastatin and none on ezetimibe/simvastatin).
Stolk MF, Becx MC, Kuypers KC, Seldenrijk CA. (2006). Severe hepatic side effects of ezetimibe. Clin Gastroenterol Hepatol. (Two patients with severe but clinically distinct liver injury; 52 year old woman developed jaundice 4 months after ezetimibe was added to atorvastatin therapy, but both were continued for another 6 months [bilirubin 5.4 mg/dL, ALT 179 U/L, Alk P 1345 U/L] followed by a chronic cholestatic course and biopsy showing bile duct paucity; 58 year old man developed abdominal pain and nausea 2 months after adding ezetimibe to chronic atorvastatin therapy [bilirubin 0.9 mg/dL, ALT 575 U/L, Alk P 116 U/L, SMA positive], responding ultimately to a course of prednisone).
Goldberg RB, Guyton JR, Mazzone T, Weinstock RS, Polis A, Edwards P, Tomassini JE, et al. (2006). Ezetimibe/simvastatin vs atorvastatin in patients with type 2 diabetes mellitus and hypercholesterolemia: the VYTAL study. Mayo Clin Proc. (Controlled trial of atorvastatin vs simvastatin/ezetimibe in 1229 patients with diabetes and hypercholesterolemia; confirmed ALT elevations above 3 times ULN occurred in 0.3% of atorvastatin vs no simvastatin/ezetimibe treated patients, and no clinically apparent liver injury).
Bhardwah SS, Chalasani N. (2007). Lipid-lowering agents that cause drug-induced hepatotoxicity. Clin Liver Dis. (Review of hepatotoxicity of lipid lowering agents; cases of acute cholestatic and autoimmune hepatitis-like injury from ezetimibe have been reported).
Ose L, Johnson-Levonas A, Reyes R, Lin J, Shah A, Tribble D, Musliner T, Vytorin Extension Study Group. (2007). A multi-centre, randomised, double-blind 14-week extension study examining the long-term safety and efficacy profile of the ezetimibe/simvastatin combination tablet. Int J Clin Pract. (Continuation of trial described by Bayes [2004] with 1104 patients continuing in an extension study of simvastatin vs simvastatin/ezetimibe in various dosages; confirmed ALT elevations above 3 times ULN occurred in 1.3% on simvastatin alone and 1.5% on the combination; no cases of clinically apparent liver injury).
Tuteja S, Pyrsopoulos NT, Wolowich WR, Khanmoradi K, Levi DM, Selvaggi G, Weisbaum G, et al. (2008). Simvastatin-ezetimibe-induced hepatic failure necessitating liver transplantation. Pharmacotherapy. (70 year old woman developed acute liver failure 10 weeks after addition of ezetimibe to long term simvastatin therapy [1.5 years] [bilirubin 0.4 rising to 23.7 mg/dL, ALT 842 to 2595 U/L, Alk P 217 U/L], INR rising to 2.0 and emergency liver transplant: Case 2).
Liu Q, Tobias H, Petrovic LM. (2007). Drug-induced liver injury associated with ezetimibe therapy. Dig Dis Sci. (75 year old woman developed elevated liver tests 6 months after starting ezetimibe without a statin [bilirubin 0.9 mg/dL, ALT 731 U/L, Alk P 149 U/L, ANA 1:320], resolution within 4 months of stopping).
Guyton JR, Brown BG, Fazio S, Polis A, Tomassini JE, Tershakovec AM. (2008). Lipid-altering efficacy and safety of ezetimibe/simvastatin coadministered with extended-release niacin in patients with type IIa or type IIb hyperlipidemia. J Am Coll Cardiol. (Controlled trial comparing niacin alone vs simvastatin/ ezetimibe vs all three for 24 weeks in 1220 patients with hypercholesterolemia; confirmed ALT elevations above 3 times ULN occurred in 0.4% on niacin, 0.4% on simvastatin/ezetimibe, and 0.5% on all three).
Castellote J, Ariza J, Rota R, Girbau A, Xiol X. (2008). Serious drug-induced liver disease secondary to ezetimibe. World J Gastroenterol. (56 year old woman developed jaundice and pruritus 2 months after starting ezetimibe without a statin or other lipid lowering medication [bilirubin 35.2 mg/dL, ALT 1575 U/L, Alk P 115 U/L], resolving within 4 weeks of stopping therapy).
Florentin M, Liberopoulos EN, Elisaf MS. (2008). Ezetimibe-associated adverse effects: what the clinician needs to know. Int J Clin Pract. (Review of safety and toxicity of ezetimibe; rate of ALT elevations above 3 times ULN reported to be the same with ezetimibe as with placebo, but higher rates found with combinations of ezetimibe and statins [1.3% vs 0.4% with statin alone]; 4 cases of clinically apparent liver injury have appeared in the published literature).
Ritchie SR, Orr DW, Black PN. (2008). Severe jaundice following treatment with ezetimibe. Eur J Gastroenterol Hepatol. (49 year old woman developed jaundice 4 months after starting ezetimibe [bilirubin 37.8 mg/dL but ALT and Alk P normal], with cirrhosis on liver biopsy, high bilirubin levels fell to 2.1 mg/dL 4 months later; jaundice possibly related to competition between ezetimibe and bilirubin for excretion by MRP2, the protein deficient in Dubin-Johnson syndrome).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug-Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 3 cases were attributed to the combination of simvastatin and ezetimibe, but no details provided).
Robinson JG, Ballantyne CM, Grundy SM, Hsueh WA, Parving HH, Rosen JB, Adewale AJ, et al. (2009). Lipid-altering efficacy and safety of ezetimibe/simvastatin versus atorvastatin in patients with hypercholesterolemia and the metabolic syndrome (from the VYMET study). Am J Cardiol. (Controlled trial of ezetimibe/simvastatin versus atorvastatin alone in 1128 patients with metabolic syndrome and hypercholesterolemia; adverse event rates were similar in the two groups, but consecutive ALT or AST elevations above 3 times ULN occurred in 0.3% of atorvastatin vs 1.4% of ezetimibe/simvastatin treated patients).
McGinnis B, Schimmer J, Hutka K. (2010). An evaluation of alanine transaminase and creatine kinase elevations with the use of ezetimibe in an ambulatory care setting. J Clin Lipidol. (Among 4332 patients treated with ezetimibe in an ambulatory care setting, 44 [1.1%] had an ALT elevation above 3 times ULN, but many of the 44 had other reasons for the abnormalities).
Foody JM, Brown WV, Zieve F, Adewale AJ, Flaim D, Lowe RS, Jones-Burton C, Tershakovec AM. (2010). Safety and efficacy of ezetimibe/simvastatin combination versus atorvastatin alone in adults ≥65 years of age with hypercholesterolemia and with or at moderately high/high risk for coronary heart disease (the VYTELD study). Am J Cardiol. (Among 1289 elderly patients with hypercholesterolemia treated with atorvastatin or the combination of ezetimibe and simvastatin for 12 weeks, adverse events were similar in the two groups, ALT values rose above 3 times ULN in 0.4% vs 0.4% of subjects and none developed clinically apparent hepatitis).
Bays HE, Davidson MH, Massaad R, Flaim D, Lowe RS, Tershakovec AM, Jones-Burton C. (2011). Safety and efficacy of ezetimibe added on to rosuvastatin 5 or 10 mg versus up-titration of rosuvastatin in patients with hypercholesterolemia (the ACTE Study). Am J Cardiol. (Trial of adding ezetimibe to rosuvastatin vs increasing the dose in 440 patients followed for 6 weeks; only one of 221 patients on the combination vs none on the increased dose of rosuvastatin had an ALT elevation above 3 times ULN).
Toth PP, Morrone D, Weintraub WS, Hanson ME, Lowe RS, Lin J, Shah AK, Tershakovec AM. (2012). Safety profile of statins alone or combined with ezetimibe: a pooled analysis of 27 studies including over 22,000 patients treated for 6-24 weeks. Int J Clin Pract. (Analysis of side effects from 27 controlled trials in 22,000 patients found ALT or AST elevations above 3 times ULN in 0.35% vs 0.56% of those receiving a statin alone vs its combination with ezetimibe, and no cases of clinically apparent liver injury).
Rosen JB, Jimenez JG, Pirags V, Vides H, Hanson ME, Massaad R, McPeters G, et al. (2013). A comparison of efficacy and safety of an ezetimibe/simvastatin combination compared with other intensified lipid-lowering treatment strategies in diabetic patients with symptomatic cardiovascular disease. Diab Vasc Dis Res. (None of 321 patients who were treated with simvastatin and ezetimibe for six weeks had ALT or AST elevations above 3 times ULN).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 2 attributed to atorvastatin and 1 to simvastatin, but none to ezetimibe).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to ezetimibe or other cholesterol lowering agents).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 41 [5.4%] were attributed to lipid lowering agents including 2 to the combination of simvastatin and ezetimibe, but none to ezetimibe alone).
Cannon CP, Blazing MA, Giugliano RP, McCagg A, White JA, Theroux P, Darius H, et al. (2015). IMPROVE-IT Investigators. Ezetimibe added to statin therapy after acute coronary syndromes. N Engl J Med. (Among 18,144 patients with an acute coronary syndrome and hypercholesterolemia treated with simvastatin [40 mg daily] with or without ezetimibe for a median duration of 6 years, LDL-cholesterol levels were lower [54 vs 70 mg/dL] and atherosclerotic event rates less with addition of ezetimibe [33% vs 35%], while adverse event rates were similar, including ALT or AST elevations above 3 times ULN [2.5% vs 2.3%] and no liver related serious adverse events were mentioned).
Kusters DM, Caceres M, Coll M, Cuffie C, Gagné C, Jacobson MS, Kwiterovich PO, et al. (2015). Efficacy and safety of ezetimibe monotherapy in children with heterozygous familial or nonfamilial hypercholesterolemia. J Pediatr. (Among 138 children with hypercholesterolemia who were treated with ezetimibe or placebo for 12 weeks, LDL-cholesterol decreased by 27% and ezetimibe was "well tolerated", ALT elevations above 3 times ULN occurring in only 1 patient in whom values rose to 145 U/L [bilirubin and Alk P normal] and led to early discontinuation when ALT levels remained elevated for more than a month).
Moriarty PM, Thompson PD, Cannon CP, Guyton JR, Bergeron J, Zieve FJ, Bruckert E, et al. (2015). ODYSSEYALTERNATIVE Investigators. Efficacy and safety of alirocumab vs ezetimibe in statin-intolerant patients, with a statin rechallenge arm: The ODYSSEYALTERNATIVE randomized trial. J Clin Lipidol. (Among 313 patients with hypercholesterolemia and statin intolerance treated with alirocumab or ezetimibe or atorvastatin for 24 weeks, alirocumab produced greater reductions in LDL-cholesterol than ezetimibe with slightly lower rates of myalgia than atorvastatin [25% vs 27%] and there were no ALT elevations above 3 times ULN in any group).
Kim KJ, Kim SH, Yoon YW, Rha SW, Hong SJ, Kwak CH, Kim W, et al. (2016). Effect of fixed-dose combinations of ezetimibe plus rosuvastatin in patients with primary hypercholesterolemia: MRS-ROZE (Multicenter Randomized Study of ROsuvastatin and eZEtimibe). Cardiovasc Ther. (Among 412 patients with hypercholesterolemia who were treated with rosuvastatin with vs without ezetimibe for 8 weeks, there were no serious adverse events and transient ALT elevations above 3 times ULN arose in only 1 patient in each group [0.5% vs 0.5%]).
Jones PH, Bays HE, Chaudhari U, Pordy R, Lorenzato C, Miller K, Robinson JG. (2016). Safety of alirocumab (a PCSK9 monoclonal antibody) from 14 randomized trials. Am J Cardiol. (Among 5234 patients treated with alirocumab or placebo or ezetimibe in 14 controlled trials, overall adverse event rates, including serious events and deaths, were similar in the three groups, although local injection reactions were more common with alirocumab; rates of ALT elevations were also similar [2.7 and 2.9% vs 2.3% with placebo and 2.6% with ezetimibe] and there were no cases of ALT elevations with jaundice that could not be attributed to other causes [2 in patients treated with alirocumab, 2 with placebo, none with ezetimibe]).
Oikawa S, Yamashita S, Nakaya N, Sasaki J, Kono S, Effect of Fenofibrate and Ezetimibe Combination Treatment on Lipid (EFECTL) Study Investigators. (2017). Efficacy and safety of long-term coadministration of fenofibrate and ezetimibe in patients with combined hyperlipidemia: results of the EFECTL study. J Atheroscler Thromb. (Among 236 Japanese patients with hyperlipidemia treated with fenofibrate, ezetimibe or both for 52 weeks, ALT elevations occurred in 0% on ezetimibe, 3.8% on fenofibrate and 1.9% on both, and all changes were considered "comparatively mild").
El Shahawy M, Cannon CP, Blom DJ, McKenney JM, Cariou B, Lecorps G, Pordy R, Chaudhari U, Colhoun HM, et al. (2017). Efficacy and safety of alirocumab versus ezetimibe over 2 years (from ODYSSEY COMBO II). Am J Cardio. (Among 720 patients with inadequate control of cholesterol levels with maximal doses of statins who were treated with alirocumab or ezetimibe for up to 2 years, adverse event rates were similar, ALT elevations above 3 times ULN occurred in 2.1% on alirocumab vs 0.8% on ezetimibe, but the abnormalities were usually a single value and no patient developed clinically apparent liver injury).
Hong SJ, Jeong HS, Ahn JC, Cha DH, Won KH, Kim W, Cho SK, et al. (2018). A phase III, multicenter, randomized, double-blind, active comparator clinical trial to compare the efficacy and safety of combination therapy with ezetimibe and rosuvastatin versus rosuvastatin monotherapy in patients with hypercholesterolemia: I-ROSETTE (Ildong Rosuvastatin & Ezetimibe for Hypercholesterolemia) randomized controlled trial. Clin Ther. (Among 396 Korean patients with hypercholesterolemia treated with rosuvastatin [5, 10 or 20 mg daily] with or without ezetimibe [10 mg daily] for 8 weeks, the percent decrease in LDL-cholesterol was higher at each dose of rosuvastatin combined with ezetimibe [overall -57% vs -44%] and the proportion of patients achieving a targeted goal of LDL-cholesterol was also higher [92% vs 80%], while there were similar rates of total adverse events [11.2% vs 11.3%], serious adverse events [0.5% vs 0.5%] as well as ALT elevations above 3 times the ULN [0.6% vs 0]).
(2019). Lipid-lowering drugs. Med Lett Drugs Ther. (Concise review of the mechanism of action, relative efficacy, safety and costs of lipid lowering drugs including statins, ezetimibe, PCSK9 inhibitors, bile acid sequestrants, fibric acid derivatives niacin and fish oil, mentions that statin therapy is associated with ALT elevations above 3 times ULN in 1-3% of patients but “whether statins actually cause liver damage is unclear”).
Kanagalingam T, Lazarte J, Wong DKH, Hegele RA. (2020). Liver injury associated with ezetimibe monotherapy. CJC Open. (59 year old white man with hyperlipidemia developed anorexia, arthralgia, abdominal pain and itching 2-3 months after starting ezetimibe monotherapy [bilirubin 0.8 mg/dL, ALT 300 U/L, Alk P 1344 U/L, INR 1.0, ANA positive,] with little improvement on stopping until prednisone was added with resolution of liver abnormalities, but continued therapy with azathioprine).

## OTHER REFERENCE LINKS

1 Recent References on Ezetimibe: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=ezetimibe+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Ezetimibe: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=ezetimibe)